# Trastuzumab Deruxtecan

## OVERVIEW

### Introduction

Trastuzumab deruxtecan (also known as fam-trastuzumab deruxtecan) is a monoclonal antibody to the human epidermal growth factor receptor 2 (HER2) conjugated to a cytotoxic topoisomerase inhibitor, which is used in the therapy of refractory, unresectable or metastatic breast cancer. Trastuzumab deruxtecan has been implicated in causing instances of transient, serum enzyme elevations, but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Trastuzumab (tras tooz’ ue mab) deruxtecan (de rux” tee can) is a humanized monoclonal antibody to the human epidermal growth factor receptor 2 (HER2) conjugated to deruxtecan, a cytotoxic inhibitor of topoisomerase which is used in the therapy of advanced or metastatic forms of cancer. HER2 is over-expressed in a proportion of cancers including breast, gastric, and non-small cell lung cancer. The monoclonal antibody is linked by a cleavable tetrapeptide molecule to deruxtecan, a topoisomerase inhibitor. Binding of trastuzumab conjugate to the HER2 receptor leads to its uptake by HER2-expressing cancer cells, where intracellular lysosomal enzymes cleave the conjugate releasing the topoisomerase inhibitor which causes growth arrest and apoptotic cell death. Trastuzumab was shown to decrease recurrences and prolong survival in women with HER2 positive breast cancer who had failed to respond to conventional chemotherapy including other anti-HER2-based agents. Trastuzumab was approved for use in the United States in 2019 and current indications include unresectable or metastatic breast, gastric, and non-small cell lung cancers (NSCLC) that express HER2 and have failed previous therapies. Trastuzumab deruxtecan is available in single use vials of 100 mg lyophilized powder under the brand name Enhertu. The recommended dose varies by indication, but is generally 5.4 or 6.4 mg/kg given intravenously every three weeks until disease progression or intolerability. Side effects are common and include fatigue, nausea and vomiting, diarrhea, constipation, decreased appetite, myalgia, headache, fever, cough, dyspnea, infusion reactions, neutropenia, anemia and thrombocytopenia. Uncommon but serious adverse events include severe infusion reactions, interstitial lung disease, neutropenic fever, infections, QTc prolongation, heart failure, and embryo-fetal toxicity. Pretreatment with antiemetics before each infusion is recommended as is monitoring for neutropenia, left ventricular dysfunction, and symptoms of pulmonary toxicity. Trastuzumab deruxtecan should be prescribed and administered only by health care workers with expertise and experience in cancer chemotherapy and management of its adverse events.

### Hepatotoxicity

In large registration trials, therapy with trastuzumab deruxtecan was linked to serum aminotransferase elevations in 34% to 53% of patients, but in most studies levels rose to above 5 times the upper limit of normal (ULN) in only 1% to 2% of treated participants. Furthermore, no instances of acute liver injury or deaths from hepatic failure were reported. Since its initial approval and more expanded indications and widespread use, trastuzumab deruxtecan has continued to be linked to appreciable rates of serum aminotransferase elevations during therapy, but has not been convincingly linked to cases of clinically apparent liver injury.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations during trastuzumab deruxtecan therapy has not been fully defined, but is most likely due to the topoisomerase rather than the monoclonal antibody of the drug-antibody conjugate.

### Outcome and Management

The serum enzyme elevations attributed to trastuzumab alone and to trastuzumab deruxtecan have been self-limited and not associated with symptoms or jaundice. There is no information on possible cross sensitivity to the injury among different monoclonal antibodies or therapies directed at epidermal growth factor receptors. In contrast, the monoclonal conjugate trastuzumab emtansine has been linked to acute liver injury with symptoms and jaundice, probably representing sinusoidal obstruction syndrome. More marked serum aminotransferase elevations (above 5 times ULN) arising during therapy with trastuzumab deruxtecan and trastuzumab alone can generally be managed by temporary dose interruption or dose reduction.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Benlantamab Mafodotin, Brentuximab Vedotin, Enfortumab Vedotin, Gemtuzumab Ozogamicin, Inotuzumab Ozogamicin, Polatuzumab Vedotin, Sacituzumab Govitecan, Tisotumab Vedotin, Trastuzumab Emtansine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trastuzumab Deruxtecan – Enhertu®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Trastuzumab%20Deruxtecan) (Trastuzumab Deruxtecan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Trastuzumab | 180288-69-1 (https://pubchem.ncbi.nlm.nih.gov/compound/Trastuzumab) | Monoclonal Antibody | Not Available
Trastuzumab Deruxtecan | 1826843-81-5 | Monoclonal Antibody with Microtubular Inhibitor | SID: 381128090
Trastuzumab Emtansine | 1018448-65-1 | Monoclonal Antibody with Microtubular Inhibitor | SID: 135353969

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2024

Abbreviations: CT, computerized tomography; HER2, human epidermal growth factor receptor 2; MR, magnetic resonance; NRH, nodular regenerative hyperplasia.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999; well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive drugs mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/761139Orig1s000MultidisciplineR.pdf (FDA website medical review of data on safety and efficacy provided by the sponsor in support of the 2019 approval of trastuzumab deruxtecan as therapy of refractory metastatic HER2 breast cancer, mentions that ALT elevations occurred in 10% to 38% of patients during therapy which were above 5 times ULN in 1% or less, and that there were no hepatic serious adverse events or deaths from hepatic failure).
Cobleigh MA, Vogel CL, Tripathy D, Robert NJ, Scholl S, Fehrenbacher L, Wolter JM, et al. Multinational study of the efficacy and safety of humanized anti-HER2 monoclonal antibody in women who have HER2-overexpressing metastatic breast cancer that has progressed after chemotherapy for metastatic disease. J Clin Oncol 1999; 17: 2639-48. (Among 222 women with HER2 overexpressing metastatic breast cancer who were treated with anti-HER2 monoclonal antibody once weekly, one developed an anaphylactoid reaction and 20 [9%] had grade 3, and 7 [3%] grade 4 hepatic adverse events [mostly ALT or Alk P elevations], usually in those with progressive disease involving the hepatobiliary system; no mention of clinically apparent liver injury with jaundice). 10561337
Muñoz A, Carrera S, Ferreiro J, de Lobera AR, Mañé JM, López-Vivanco G. Reversible liver toxicity with adjuvant trastuzumab for localized breast cancer. Ann Oncol 2007; 18: 2045-6. (31 year old woman with breast cancer developed marked ALT elevations [1403 U/L] after first infusion of trastuzumab [8 mg/kg], which resolved within 4 weeks and did not recur with subsequent lower dose regimens, although minor ALT continued to occur thereafter). 18083694
Srinivasan S, Parsa V, Liu CY, Fontana JA. Trastuzumab-induced hepatotoxicity. Ann Pharmacother 2008; 42: 1497-501. (54 year old woman with breast cancer on paclitaxel and trastuzumab developed progressive increases in ALT, starting with first dose and resulting in discontinuation after 8th cycle, falling to normal thereafter). 18780811
Verma S, Miles D, Gianni L, Krop IE, Welslau M, Baselga J, Pegram M, et al.; EMILIA Study Group. Trastuzumab emtansine for HER2-positive advanced breast cancer. N Engl J Med 2012; 367: 1783-91. (Among 991 women with HER2 expressing breast cancer who had failed previous therapy who received either trastuzumab emtansine or lapatinib with capecitabine, overall survival was improved with the antibody conjugate, but ALT levels were elevated in 17%, AST in 22%, and platelets decreased in 28% of patients; 3 patients stopped therapy early because of aminotransferase elevations, but no patient had both bilirubin and marked ALT elevations and there were no liver related deaths). 23020162
Vucicevic D, Carey EJ, Karlin NJ. Trastuzumab-induced hepatotoxicity: a case report. Breast Care (Basel) 2013; 8: 146-8. (60 year old woman was found to have serum enzyme elevations without symptoms 41 days after finishing 6 months [8 cycles] of trastuzumab and while receiving trastuzumab exemestane [bilirubin 1.0 mg/dL, ALT 91 rising to 523 U/L, Alk P 100 rising to 231 U/L, INR 0.94], resolving incompletely 4 months later). 24419371
Ado-trastuzumab emtansine (Kadcyla) for HER2-positive metastatic breast cancer. Med Lett Drugs Ther 2013; 55 (1425): 75-6. (Concise summary of mechanism of action, efficacy, safety and costs of ado-trastuzumab emtansine, a conjugate of trastuzumab with a microtubule inhibitor mentions that increased aminotransferase levels occurred in more than 25% of patients and serious, sometimes fatal, liver toxicity has been reported). 24662957
Force J, Saxena R, Schneider BP, Storniolo AM, Sledge GW Jr, Chalasani N, Vuppalanchi R. Nodular regenerative hyperplasia after treatment with trastuzumab emtansine. J Clin Oncol 2016; 34 (3): e9-12. (Two women, ages 66 and 50 years, with metastatic breast cancer presented with evidence of portal hypertension [ascites, varices, low platelet counts] 16 months after starting cyclic therapy with ado-trastuzumab emtansine [bilirubin normal, ALT 48 and ~120 U/L, Alk P 400 U/L and not given], biopsy showing nodular regenerative hyperplasia and both patients improving when the agent was stopped). 24778392
Miller KD, Diéras V, Harbeck N, Andre F, Mahtani RL, Gianni L, Albain KS, et al. Phase IIa trial of trastuzumab emtansine with pertuzumab for patients with human epidermal growth factor receptor 2-positive, locally advanced, or metastatic breast cancer. J Clin Oncol 2014; 32: 1437-44. (Among 64 women with HER2 positive metastatic breast cancer [HER2 positive] treated with the combination of pertuzumab and trastuzumab emtansine [every 3 weeks], common side effects were fatigue [61%], nausea [50%] and diarrhea [39%] and "hepatic dysfunction" in 38% with ALT levels above 5 times ULN in 9%). 24733796
Ishizuna K, Ninomiya J, Ogawa T, Tsuji E. Hepatotoxicity induced by trastuzumab used for breast cancer adjuvant therapy: a case report. J Med Case Rep 2014; 8: 417. (60 year old Japanese woman with breast cancer developed liver test abnormalities after a second cycle of trastuzumab [bilirubin normal, ALT 246 U/L, Alk P 553 U/L] which recurred one year later after readministration of a single infusion [bilirubin normal, ALT 102 U/L, Alk P 377 U/L], resolving within 2 months of stopping). 25491149
Yan H, Endo Y, Shen Y, Rotstein D, Dokmanovic M, Mohan N, Mukhopadhyay P, et al. Ado-trastuzumab emtansine targets hepatocytes via human epidermal growth factor receptor 2 to induce hepatotoxicity. Mol Cancer Ther 2016; 15: 480-90. (In cultured human and mouse hepatocytes and in mouse models, trastuzumab emtansine can cause hepatocellular injury after binding to cell surface HER2 receptors and uptake into hepatocytes). 26712117
Liu Y, Li ZY, Li X, Wang JN, Huang QA, Huang Y. Liver toxicity of chemotherapy and targeted therapy for breast cancer patients with hepatitis virus infection. Breast 2017; 35: 191-195. (Among 835 patients with breast cancer receiving targeted therapy, rates of ALT elevations were slightly higher in the 52 with HBsAg [35%] and the 21 with anti-HCV [43%] than controls [28%], as were rates of chemotherapy disruption for liver test abnormalities [9.6% and 9.5% vs 5%], but no patient developed viral reactivation, although the proportion of those with HBsAg who were receiving antiviral prophylaxis was not provided). 28800545
Hidalgo-Blanco A, Aguirresarobe-Gil de San Vicente M, Aresti S, de Miguel E, Cabriada-Nuno JL. Pseudocirrhosis in metastatic breast cancer. Gastroenterol Hepatol 2018; 41: 111-3. (39 year old woman with HER2 positive breast cancer received a 1 year course of trastuzumab at the end of which she had normal ALT levels and CT appearance of the liver, but 18 months later she presented with abnormalities of both suggestive of pseudocirrhosis). 28187872
Fujii Y, Doi M, Tsukiyama N, Hattori Y, Ohya K, Shiroma N, Morio K, et al. Sinusoidal obstruction syndrome post-treatment with trastuzumab emtansine (T-DM1) in advanced breast cancer. Int Cancer Conf J 2019; 9: 18-23. (Two women with metastatic HER2 positive breast cancer developed noncirrhotic portal hypertension 2.5 and 4.5 years of trastuzumab emtansine therapy, in both of whom liver biopsy showed sinusoidal obstruction syndrome and disordered hepatic plates). 31950012
Modi S, Saura C, Yamashita T, Park YH, Kim SB, Tamura K, Andre F, et al.; DESTINY-Breast01 Investigators. Trastuzumab deruxtecan in previously treated HER2-positive breast cancer. N Engl J Med. 2020;382:610-621. (Among 184 patients with unresectable or metastatic refractory HER2 positive breast cancer treated with trastuzumab deruxtecan the objective response rate was 61% and overall adverse event rate was 99.5%, most commonly with nausea, fatigue, alopecia, vomiting, constipation, decreased appetite, and 14% of patients developed interstitial lung disease, 5% a prolonged QT interval, 2.7% infusion reactions, and ALT elevations in 12% which were above 5 times ULN in 2%; no mention of clinically apparent liver injury). 31825192
Shitara K, Bang YJ, Iwasa S, Sugimoto N, Ryu MH, Sakai D, Chung HC, et al.; DESTINY-Gastric01 Investigators. Trastuzumab deruxtecan in previously treated HER2-positive gastric cancer. N Engl J Med. 2020;382:2419-2430. (Among 187 patients with advanced, previously treated HER2 positive gastric cancer treated with trastuzumab deruxtecan or chemotherapy, the objective response rates were 51% vs 16% and overall survival 12.5 vs 8.4 months, and while overall adverse event rates were high [100% vs 98%], drug discontinuations were higher with trastuzumab deruxtecan [15%vs 6%] as were interstitial lung disease [10% vs 0%]; no mention of ALT elevations or hepatotoxicity). 32469182
Two drugs for advanced HER2-positive breast cancer (Enhertu and Tukysa). Med Lett Drugs Ther. 2020;62(1611):182-184. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of trastuzumab deruxtecan shortly after its approval in the US for use in advanced HER-2 positive breast cancer refractory to other treatments; no mention of ALT elevations or hepatotoxicity). 33429416
Narayan P, Osgood CL, Singh H, Chiu HJ, Ricks TK, Chiu Yuen Chow E, Qiu J, et al. FDA approval summary: fam-trastuzumab deruxtecan-nxki for the treatment of unresectable or metastatic HER2-positive breast cancer. Clin Cancer Res. 2021;27:4478-4485. (Summary of the data on efficacy and safety of trastuzumab deruxtecan that provided the basis for its approval as therapy of advanced or metastatic HER-2 positive breast cancer after failure of 2 previous therapies states that deaths from adverse events arose in 4% of treated subjects [2.6% from interstitial pneumonitis], but no mention of hepatotoxicity or ALT elevations). 33753456
Li BT, Smit EF, Goto Y, Nakagawa K, Udagawa H, Mazières J, Nagasaka M, et al.; DESTINY-Lung01 Trial Investigators. Trastuzumab deruxtecan in HER2-mutant non-small-cell lung cancer. N Engl J Med. 2022;386:241-251. (Among 91 patients with refractory, metastatic non-small cell lung cancer treated with trastuzumab deruxtecan, the objective response rate was 55% while the overall adverse event rate was 100%, 43% had a serious adverse event, 32% discontinued therapy because of adverse events, and 26% developed interstitial lung disease which was fatal in 2 subjects; no mention of ALT elevations or hepatotoxicity). 34534430
Cortés J, Kim SB, Chung WP, Im SA, Park YH, Hegg R, Kim MH, et al.; DESTINY-Breast03 Trial Investigators. Trastuzumab deruxtecan versus trastuzumab emtansine for breast cancer. N Engl J Med. 2022; 386: 1143-1154. (Among 524 patients with refractory, advanced or metastatic HER2-positive breast cancer treated with trastuzumab deruxtecan or trastuzumab emtansine, progression free survival at 1 year was 76% vs 34% and adverse event rates 98% vs 87%, with deruxtecan having higher rates of neutropenia and anemia but lower rates of ALT elevations [19.5% vs 27%] which were above 5 times ULN in 1.6% vs 4.6%). 35320644
In brief: Fam-trastuzumab deruxtecan (Enhertu) for breast cancer. Med Lett Drugs Ther. 2023;65: e60-e61. (Concise review of the clinical efficacy, safety, and cost of trastuzumab deruxtecan as a second line therapy of unresectable or metastatic breast cancer that is either HER2 positive or HER2-low, mentions that therapy can be associated with elevations in “liver enzymes”). 37020344
Yoshino T, Di Bartolomeo M, Raghav K, Masuishi T, Loupakis F, Kawakami H, Yamaguchi K, et al.; DESTINY-CRC01 investigators. Final results of DESTINY-CRC01 investigating trastuzumab deruxtecan in patients with HER2-expressing metastatic colorectal cancer. Nat Commun. 2023;14:3332. (Among 58 patients with metastatic HER2 positive refractory colorectal cancer treated with trastuzumab deruxtecan [6.4 mg/kg every 3 weeks], the objective response rate was 45% [all “partial”], mean overall survival was 15.5 months, adverse event rate was 100%, interstitial lung disease arose in 7% with 3 deaths; no mention of ALT elevations or hepatotoxicity). 37286557
Ma P, Tian H, Shi Q, Liu R, Zhang Y, Qi X, Chen Y. High risks adverse events associated with trastuzumab emtansine and trastuzumab deruxtecan for the treatment of HER2-positive/mutated malignancies: a pharmacovigilance study based on the FAERS database. Expert Opin Drug Saf. 2023;22:685-696. (Analysis of the FDA Adverse Event Reporting System [FARES] from 2004 to 2022 identified 2113 reports for trastuzumab emtansine [Tm] and 1269 for trastuzumab deruxtecan [Td], and while liver test abnormalities were reported with both, Tm had high report rates of hepatic cirrhosis [n=35], portal hypertension [24], and nodular regenerative hyperplasia [17], while Td had none for these diagnoses). 37068935
Van Cutsem E, di Bartolomeo M, Smyth E, Chau I, Park H, Siena S, Lonardi S, et al. Trastuzumab deruxtecan in patients in the USA and Europe with HER2-positive advanced gastric or gastroesophageal junction cancer with disease progression on or after a trastuzumab-containing regimen (DESTINY-Gastric02): primary and updated analyses from a single-arm, phase 2 study. Lancet Oncol. 2023;24:744-756. (Among 79 patients with advanced HER2-positive gastric or gastro-esophageal junction cancer treated with trastuzumab deruxtecan [5.4 mg/kg], the objective response rate was 30% [3 were complete], and adverse events were frequent including ALT elevations in 9%, 1% were above 5 times ULN, but there were no hepatic severe adverse events reported). 37329891
Goto K, Goto Y, Kubo T, Ninomiya K, D, Ahn MJ, et al. Trastuzumab deruxtecan in patients with HER2-mutant metastatic non-small-cell lung cancer: primary results from the randomized, phase II DESTINY-Lung02 Trial. J Clin Oncol. 2023;41:4852-4863. (Among 152 patients with metastatic, refractory HER2-mutant NSCLC treated with trastuzumab deruxtecan in doses of 5.4 or 6.4 mg/kg every 3 weeks, the objective response rates were 49% vs 56% and adverse event rates 100% in both, but most adverse events were less frequent with the lower dose, nausea being reported in 67% vs 82% and interstitial lung disease in 13% vs 28%, the exception being ALT elevations in 22% vs 20%, which were above 5 times ULN in 3% vs 0%). 37694347
Meric-Bernstam F, Makker V, Oaknin A, Oh DY, Banerjee S, González-Martín A, Jung KH, et al. Efficacy and safety of trastuzumab deruxtecan in patients with HER2-expressing solid tumors: primary results from the DESTINY-PanTumor02 phase II trial. J Clin Oncol. 2024;42:47-58. (Among 267 patients with refractory, advanced or metastatic, HER2-positive tumors [7 types] treated with trastuzumab deruxtecan, the objective response rate was 37% with responses in all groups [lowest in pancreatic cancer], and adverse events being common with 28 [11%] cases of interstitial lung disease [3 fatal], but no mention of ALT elevations or hepatotoxicity). 37870536
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the Food and Drug Administration adverse event reporting system. Expert Opin Drug Saf. 2023:1-12. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], trastuzumab deruxtecan [n=8], and polatuzumab vedotin [3]). 37898875

## OTHER REFERENCE LINKS

Recent References on Trastuzumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Trastuzumab+Deruxtecan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Trastuzumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trastuzumab%20Deruxtecan)